# Licorice

## OVERVIEW

### Introduction

Licorice is the common name of the plant Glycyrrhiza glabra, the roots of which are widely used as a flavoring in food, candy and tobacco, and extracts of which have been used in traditional medicine for the treatment of many conditions, including gastrointestinal disorders, upper respiratory infections, and symptoms of menopause and premenstrual tension. Licorice when given in high doses has many serious adverse events, but has not been reported to cause serum aminotransferase elevations or clinically apparent liver injury.

### Background

Licorice is a flavoring agent as well as an herbal supplement prepared from the roots and runners of Glycyrrhiza glabra, a herbaceous flowering plant found in Mediterranean areas of Europe and Africa, the Middle East, and Asia. The roots of Glycyrrhiza glabra have a sweet aroma, and extracts are used to sweeten and flavor tobacco, food, and candy. Extracts of licorice root have also been used in traditional medicine for a variety of conditions including ulcer disease, constipation, nausea, upper respiratory illnesses, cough, fever, and menopausal and premenstrual symptoms of women. The constituents in licorice root responsible for its sweetness and aroma are volatile oils similar to those found in anise and fennel flavorings. The medicinal components of licorice are not precisely known but are usually attributed to flavonoids, flavones, saponins, and chalcones. A major component of licorice root (ranging from 4% to 12%) is glycyrrhizin or glycyrrhizinic acid, an astringent molecule with corticosteroid-like activities. Glycyrrhizin has been used to treat several disorders including chronic hepatitis C, where it is given intravenously two or three times weekly. The evidence for its efficacy in hepatitis C, however, is not widely accepted, and it has now been replaced by the highly efficacious direct acting HCV antivirals. Nevertheless, studies in cell culture and in animal models have repeatedly found that glycyrrhizin and licorice extracts decrease or prevent liver injury from a variety of insults including chemotherapeutic agents, acetaminophen, prescription drugs, obesity and ischemia. However, glycyrrhizin also has known toxicities in animals and humans that are attributed to its mineralocorticoidal actions, for which reason some licorice extracts are deglycyrrhinized. Orally available licorice with or without glycyrrhizin is used in many herbal preparations for its purported medicinal activities as well as for its flavor and sweetness. Licorice is not licensed for any medical condition in the United States by the FDA, but over-the-counter extracts are available and purported to be beneficial for general health, gastrointestinal health, liver wellness, menopausal symptoms and many other conditions. None of these claims, however, has been demonstrated in properly designed and adequately powered prospective studies. While generally regarded as safe (GRAS) in amounts found in food, licorice extracts in high doses can cause serious adverse effects due to its mineralocorticoidal activities resulting in systemic arterial hypertension, hypokalemia, sodium and water retention, muscle weakness, paralysis, and cardiac arrhythmias. Deaths from hypermineralocorticoidal effects have been reported in patients taking high doses of oral licorice in teas or as extracts in capsules or tablets. Licorice is also an abortifacient and has estrogenic and corticosteroid effects that can result in fetal toxicity or loss and should not be used during pregnancy.

### Hepatotoxicity

In multiple clinical studies of different preparations of licorice or glycyrrhizin in conventional doses, adverse side effects were usually described as uncommon and transient. In studies that included measurements of routine liver tests, there were no episodes of serious elevations in serum ALT or AST and no instances of clinically apparent liver injury. There have been no single case reports of liver injury due to licorice and large case series and registries of drug- and dietary supplement induced liver injury, and licorice has not been listed as an implicated agent.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which licorice extracts and glycyrrhizin might cause liver injury is unknown.

### Outcome and Management

Hepatotoxicity from licorice extracts or glycyrrhizin has not been reported.

Drug Class: Herbal and Dietary Supplements

Other names: Glycyrrhizin, Sweet Root, Liquorice

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Licorice – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at National Center for Complementary and Integrative Health, NIH (https://www.nccih.nih.gov/health/licorice-root)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Glycyrrhizin | 1405-86-3 | C42-H62-O16

## ANNOTATED BIBLIOGRAPHY

References updated: 20 March 2023

Abbreviations: HbA1c, hemoglobin A1c; HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not licorice).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2007; no mention of licorice or glycyrrhizin).
Licorice. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 522-530. (Compilation of short monographs on herbal medications and dietary supplements).
Wikipedia. https://en.wikipedia.org/wiki/Liquorice (Wikipedia website providing a concise description of licorice, its etymology, chemistry, cultivation, uses, medical properties, and toxicities).
Tominaga Y, Nakagawa K, Mae T, Kitano M, Yokota S, Arai T, Ikematsu H, et al. (2009). Licorice flavonoid oil reduces total body fat and visceral fat in overweight subjects: a randomized, double-blind, placebo-controlled study. Obes Res Clin Pract. (Among 80 overweight adults treated with liquid licorice flavored oil [300, 600 or 900 mg] or placebo daily for 8 weeks, total body fat decreased with licorice therapy compared to placebo despite similar daily caloric intake and in higher does, total body weight was also decreased, while bilirubin, ALT, AST and alkaline phosphatase levels did not change appreciably in either group).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals in a Swedish Registry does not list licorice among products associated with 5 or more reports).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, including several herbal mixtures, usnic acid, Ma Huang, black cohosh, and Hydroxycut, but not licorice).
Vitalone A, Menniti-Ippolito F, Raschetti R, Renda F, Tartaglia L, Mazzanti G. (2012). Surveillance of suspected adverse reactions to herbal products used as laxatives. Eur J Clin Pharmacol. (Among 26 reports of adverse events from HDS products reported to the Italian Medicines Agency between 2002 and 2011, 7 implicated products contained licorice among other agents; the adverse reactions being urticaria in 2, gastrointestinal complaints in 2, photophobia in 1, electrolyte disturbance in 1 and only abdominal pain and aminotransferase elevations in 1 attributed to a product with 10 other herbal components including aloe vera and senna).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements, but none listed licorice as an ingredient).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury does not mention licorice).
Navarro VJ, Seeff LB. (2013). Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal and traditional herbal remedies).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products but no case was attributed specifically to licorice or glycyrrhizin).
Brown AC. (2017). Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol. (Description of an online compendium of cases of liver toxicity attributed to HDS products that does not list or discuss licorice).
Nazari S, Rameshrad M, Hosseinzadeh H. (2017). Toxicological effects of Glycyrrhiza glabra (Licorice): a review. Phytother Res. (Extensive review of the animal toxicity of glycyrrhizin and licorice focusing largely on its mineralocorticoid effects and pseudohyperaldosteronism with hypokalemia, electrolyte imbalance, hypertension, weakness, asthenia, peripheral edema, and neuromuscular paralysis; no mention of liver toxicity in humans).
Arentz S, Smith CA, Abbott J, Fahey P, Cheema BS, Bensoussan A. (2017). Combined lifestyle and herbal medicine in overweight women with polycystic ovary syndrome (PCOS): a randomized controlled trial. Phytother Res. (Among 108 overweight women [ages 18 to 44 years] with polycystic ovary syndrome treated with lifestyle modification and either two herbal preparations [one with Glycyrrhizia glabra and one with Tribulus terrestris extracts] or placebo for 3 months, oligomenorrhea was improved with the herbal therapy as were fasting insulin levels, blood pressure, body weight, and quality of life, and with no serious adverse events; no mention of ALT levels or hepatotoxicity).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al., Spanish DILI Registry. (2018). Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent implicated agents being green tea [n=8] and Herbalife products [n=6]; no mention of licorice).
Li X, Sun R, Liu R. (2019). Natural products in licorice for the therapy of liver diseases: Progress and future opportunities. Pharmacol Res. (Review of the effects of licorice on cell signaling pathways underlying its antioxidant activity and possible role as a hepatoprotective and antifibrotic agent).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; ]; licorice was not listed among the 79 implicated products).
Ng SL, Khaw KY, Ong YS, Goh HP, Kifli N, Teh SP, Ming LC, et al. Licorice: a potential herb in overcoming SARS-CoV-2 infections. J Evid Based Integr Med. 2021;26:2515690X21996662. (Commentary on licorice suggesting that its broad antiinflammatory and antimicrobial actions are reason to consider whether studies of its effects on COVID-19 are warranted).
Rostamizadeh P, Asl SMKH, Far ZG, Ahmadijoo P, Mahmudiono T, Bokov DO, Alsaikhan F, et al. (2022). Effects of licorice root supplementation on liver enzymes, hepatic steatosis, metabolic and oxidative stress parameters in women with nonalcoholic fatty liver disease: A randomized double-blind clinical trial. Phytother Res. (Among 52 Iranian women with nonalcoholic fatty liver treated with life-style modification and either licorice [1000 mg] or placebo daily for 3 months, weight loss was greater with licorice [-5.1 vs -3.8 kg] as was decrease in ALT levels [-6.6 vs -3.0 U/L], serum insulin [-4.5 vs -2.0 µU/L], and hepatic steatosis as assessed by ultrasound, and “no side effects were recorded”).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. (2022). Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while licorice is not mentioned).
Guo M, Wang Z, Dai J, Fan H, Yuan N, Gao L, Peng H, et al. (2023). Glycyrrhizic acid alleviates liver fibrosis in vitro and in vivo via activating CUGBP1-mediated IFN-γ/STAT1/Smad7 pathway. Phytomedicine. (Glycyrrhizic acid given in vitro and in vivo inhibited fibrosis formation in cell culture and animal models and the inhibitory activity appeared to be mediated by binding of glycyrrhizic acid to CUGBP2 resulting in its inhibition and interference with the gamma interferon-STAT1-SMAD7 pathway that increases stellate cell activation and fibrogenesis).

## OTHER REFERENCE LINKS

1 Recent References on Licorice: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Licorice+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Licorice: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Licorice)